# Abbreviations Used In LiverTox

The LiverTox website is written to provide comprehensive and clear information on the hepatotoxicity of medications, herbals and nutritional supplements. Abbreviations are used in the text but kept at a minimum and limited largely to those that are common in clinical practice. The following abbreviations may be encountered in LiverTox, although abbreviations will generally be introduced before use in the text. Abbreviations that are not introduced before use include: (1) routes of medication administration [e.g., intravenous, or iv] and units of measure [e.g., gram, or g]; and, (2) selected abbreviations within reference annotations.

AIDS: acquired immunodeficiency syndrome
Alk P: alkaline phosphatase
ALT: alanine aminotransferase
Anti-HAV: antibody to hepatitis A virus
Anti-HBc: antibody to hepatitis B core antigen
Anti-HBe: antibody to hepatitis B e antigen
Anti-HBs: antibody to hepatitis B surface antigen
Anti-HCV: antibody to hepatitis C virus
AST: aspartate aminotransferase
BU: Bodansky Unit
CDC: Centers for Disease Control and Prevention
CK: creatine kinase
CMV: cytomegalovirus
CT: computed tomography
DILIN: Drug Induced Liver Injury Network
EBV: Epstein-Barr virus
ERCP: endoscopic retrograde cholangiopancreatography
ESR: erythrocyte sedimentation rate
FDA: Food and Drug Administration
GGT: gamma glutamyl transpeptidase
HAV: hepatitis A virus
HBV: hepatitis B virus
HBeAg: hepatitis B e antigen
HBsAg: hepatitis B surface antigen
HCV: hepatitis C virus
HDV: hepatitis D (delta) virus
HEV: hepatitis E virus
HIV: human immunodeficiency virus
HSV: herpes simplex virus
INR: international normalized ratio (of prothrombin time)
KAU: King Armstrong Unit
LDH: lactic dehydrogenase
MRI: magnetic resonance imaging
NIH: National Institutes of Health
NLM: National Library of Medicine
Protime: Prothrombin time
RUCAM: Roussel Uclaf Causality Assessment Method
UK: United Kingdom
ULN: upper limit of the normal range
US: United States
WHO: World Health Organization

Abbreviations that are not introduced before use.

g or gm: gram
kg: kilogram
mg: milligram
µg: microgram
ng: nanogram
L: liter
dL: deciliter (100 mL)
mL: milliliter
µL: microliter
µmol: micromole
im: intramuscularly
iv: intravenously
sc: subcutaneously
U: Units
vs: versus